# Fremanezumab

## OVERVIEW

### Introduction

Fremanezumab is a monoclonal antibody to the calcitonin gene related peptide which is used for prevention of migraine in patients with episodic or chronic migraine headaches. Fremanezumab has not been associated with serum enzyme elevations during therapy nor has it been implicated in cases of clinically apparent drug induced liver injury with jaundice.

### Background

Fremanezumab (free" ma nez' ue mab) is a recombinant, humanized monoclonal antibody to the calcitonin gene related peptide (CGRP), a neuropeptide which plays an important role in migraine headaches. CGRP is a found throughout the central and peripheral nervous systems and has potent vasodilator and pain-signaling activities. Circulating levels of CGRP are elevated in patients with migraines, and the efficacy of migraine therapies (serotonin receptor agonists, ergot alkaloids) is associated with lowering of CGRP levels. Fremanezumab is a CGRP antagonist which blocks the binding of the neuropeptide to its receptor and the subsequent downstream activation of the intracellular signaling pathways. Fremanezumab was approved for use in the United States in 2018 as a means of prevention of migraine headaches and was one of three CGRP antagonists approved in 2018 for this indication (the others being erenumab and galcanezumab). Fremanezumab in available in solution in single use prefilled syringes of 225 mg under the brand name Ajovy. The recommended dose is 225 mg subcutaneously once monthly or 675 mg every 3 months. Fremanezumab is not effective as therapy of acute migraine, and it lowers the frequency but typically does not abolish all episodes of chronic migraine headaches. Side effects of fremanezumab are uncommon but can include injection site reactions and hypersensitivity reactions. Fremanezumab has not been associated with significant numbers of severe adverse events, however it has had limited general use and the effects of long term suppression of CGRP signaling are unknown but could theoretically increase the rate of serious cardiovascular or cerebrovascular ischemic events.

### Hepatotoxicity

In large clinical trials, fremanezumab was associated with isolated, rare elevations in serum aminotransferase levels during therapy (<1%), and rates of most adverse reactions were similar to those in patients who received placebo. There have been no published reports of clinically apparent acute liver injury attributed to fremanezumab therapy. Thus, significant liver injury from fremanezumab must be rare if it occurs at all.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Fremanezumab is a humanized monoclonal antibody and is unlikely to be inherently hepatotoxic. While most recombinant proteins are metabolized by the liver, the metabolism leads largely to small peptides and amino acids which may be reused to synthesize proteins and are unlikely to be toxic or immunogenic.

Drug Class: Migraine Headache Agents, Monoclonal Antibodies

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Fremanezumab – Ajovy®

DRUG CLASS

Migraine Headache Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Ergot+Alkaloids)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Fremanezumab | 1655501-53-3 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 15 April 2019

Abbreviations: CGRP, calcitonin gene related protein.

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-54. (Expert review of hepatotoxicity published in 1999, well before the availability of most monoclonal antibody therapies).
Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of monoclonal immunosuppressive agents; "the biological immuno-suppressants are largely free from hepatotoxicity, with the exception of the TNF alpha antagonists"; fremanezumab is not discussed).
https://www.accessdata.fda.gov/scripts/cder/daf/ (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy).
Bigal ME, Dodick DW, Rapoport AM, Silberstein SD, Ma Y, Yang R, Loupe PS, et al. Safety, tolerability, and efficacy of TEV-48125 for preventive treatment of high-frequency episodic migraine: a multicentre, randomised, double-blind, placebo-controlled, phase 2b study. Lancet Neurol 2015; 14: 1081-90. (Among 297 patients with episodic migraine treated with injections of fremanezumab [225 mg or 675 mg] or placebo monthly, headache days decreased more with the monoclonal antibody [-6.1 and -6.3 vs -3.5 days per month] and adverse event rates were similar: “liver enzyme concentrations were stable in the treatment phase of the study”). 26432182
Silberstein SD, Dodick DW, Bigal ME, Yeung PP, Goadsby PJ, Blankenbiller T, Grozinski-Wolff M, et al. Fremanezumab for the preventive treatment of chronic migraine. N Engl J Med 2017; 377: 2113-22. (Among 1130 patients with chronic migraine treated with injections of fremanezumab [225 mg monthly or 675 mg every 3 months] or placebo, headache days decreased more with active drug than with placebo [-4.3 and -4.6 vs -2.5 days per month] and adverse event rates were similar, although 10 treated subjects [1.3%] had transient ALT elevations which were above 5 times ULN in 2, but all were without jaundice and resolved without dose adjustment or discontinuation). 29171818
Dodick DW, Silberstein SD, Bigal ME, Yeung PP, Goadsby PJ, Blankenbiller T, Grozinski-Wolff M, et al. Effect of fremanezumab compared with placebo for prevention of episodic migraine: a randomized clinical trial JAMA 2018; 319: 1999-2008. (Among 875 adults with episodic migraine treated with fremanezumab [225 mg monthly or 625 mg every 3 months] or placebo, headache days decreased more with active drug [-3.7 and -3.4 vs -2.2 days per month] and adverse event rates were similar except for injection site reactions; while ALT or AST elevations above 3 times ULN occurred in 0.7% and 0.3% on fremanezumab vs 0% on placebo, but none were associated with jaundice or led to early discontinuation). 29800211
Edvinsson L. The CGRP pathway in migraine as a viable target for therapies. Headache 2018; 58 Suppl 1: 33-47. (Review of the calcitonin gene related peptide [CGRP] and its receptor including their relationship to migraine headaches and development of small molecular inhibitors and monoclonal antibody therapies based upon their inhibition). 29697153
Tepper SJ. History and review of anti-calcitonin gene-related peptide (CGRP) therapies: from translational research to treatment. Headache 2018; 58 Suppl 3: 238-75. (Review of the role of CGRP in pathogenesis of migraine headaches and the development of small molecules and monoclonal antibody antagonists of CGRP actions). 30242830
Hoy SM. Fremanezumab: First global approval. Drugs 2018; 78: 1829-34. (Review of the mechanism of action, pharmacokinetics, clinical efficacy and safety of fremanezumab shortly after its approval in the United States; in pooled analyses of 1904 patients, the only adverse reaction occurring more frequently with fremanezumab was injection site reactions [43-45% vs 38%] and ALT elevations above 3 times ULN occurred in less than 1% of fremanezumab treated persons). 30406901
Fremanezumab (Ajovy) and galcanezumab (Emgality) for migraine prevention. Med Lett Drugs Ther 2018; 60 (1559): 177-80. (Concise review of the mechanism of action, clinical efficacy, safety and costs of fremanezumab and galcanezumab shortly after their approval for prevention of migraine; does not mention ALT elevations or hepatotoxicity). 30681655
Silberstein SD, McAllister P, Ning X, Faulhaber N, Lang N, Yeung P, Schiemann J, et al. Safety and tolerability of fremanezumab for the prevention of migraine: a pooled analysis of phases 2b and 3 clinical trials. Headache 2019 Apr 12. [Epub ahead of print]. (Among 2566 patients with migraine enrolled in 4 placebo controlled trials of fremanezumab, states that ALT or AST elevations of at least 3 times ULN "were infrequent" and similar in rates to those treated with placebo [<1% ] and that no patient developed clinically apparent liver injury). 30977520

## OTHER REFERENCE LINKS

1. Recent References on Fremanezumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Fremanezumab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Fremanezumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Fremanezumab)